# Margosa Oil

## OVERVIEW

### Introduction

Margosa or neem oil is a yellow oil with a disagreeable smell and bitter taste that has been used as a medical remedy in India and Southeast Asia for several centuries. In recent years, there have been rare reports of acute onset of severe metabolic acidosis, hepatic and multiorgan failure and death following ingestion of margosa oil.

### Background

Margosa oil is an extract of the seeds of Azadirachta indica, commonly known as the neem tree native to India and Sri Lanka. In low doses, margosa oil has been a traditional remedy for centuries in India and Southeast Asia used in treating asthma, intestinal parasites, arthritis and leprosy. It is also an insecticide. The oil has a disagreeable smell and bitter taste attributable to volatile sulphur compounds and fatty acids. Free fatty acids account for 20% of its weight and bitters (nimbin, nimbinin, nimbidin and nibidol) for about 2%. The bitters are secondary products formed during storage of the oil or the seeds and concentrations can vary in different commercial samples.

### Hepatotoxicity

Several case reports have suggested that margosa oil can cause severe metabolic acidosis and death, particularly in young children. Symptoms of nausea, vomiting and progressive stupor develop within hours of consumption, followed by severe metabolic acidosis, coma, and progressive hepatic dysfunction, similar to Reye syndrome. Serum aminotransferase levels are generally normal or minimally elevated initially, but then rise to high levels accompanied by increases in LDH and CPK levels. Progressive hepatic encephalopathy and cerebral edema develop within days. Unexplained is why neem oil has been safely used for centuries in traditional Ayurvedic medicine. Outbreaks of this toxic syndrome have been described in India and South East Asia, suggesting that the toxicity may have been due to contamination of the ordinarily tolerated oil by seeds of plants that resemble Azadirachta indica. DNA from Azadirachta indica has been found as a contaminant in commercial herbal supplements in at least one toxicological screening report.

Likelihood score: C (known cytotoxic agent and probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of hepatotoxicity of margosa oil appears to be related to mitochondrial dysfunction and poisoning of the electron transport pathway by a component of margosa oil or a contaminant. A similar syndrome has been induced in laboratory animals with samples of the implicated oil.

### Outcome and Management

Hepatotoxicity attributed margosa oil has been reported from India and Malaysia. The clinical syndrome is similar to Reye syndrome and should be managed accordingly with electrolyte, nutritional, ventilatory and hepatic support.

Other Names: Neem oil

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Margosa Oil – Generic

DRUG CLASS

Herbal and Dietary Supplements

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Margosa Oil | 8002-65-1 | Herbal mixture | Not applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 05 February 2020

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; mentions that margosa oil has been linked to cases of liver injury resembling Reye syndrome).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS]; margosa oil is a fatty-rich extract of the seeds of the neem tree and the oil is used in treating asthma, parasites, arthritis and leprosy; in children margosa oil can cause a Reye-like syndrome).
Neem. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 599-600. (Compilation of short monographs on herbal medications and dietary supplements).
Sinniah D, Baskaran G. (1981). Margosa oil as a cause of Reye's syndrome. Lancet. (13 Malaysian children with margosa oil poisoning, with onset of vomiting within a few minutes of taking the herbal medicine, presented with drowsiness and metabolic acidosis, liver tests being usually normal but liver biopsy showing steatosis of liver and renal tubules with mitochondrial damage suggestive of Reye's syndrome).
Sinniah D, Baskaran G, Looi LM, Leong KL. (1982). Reye-like syndrome due to margosa oil poisoning: report of a case with postmortem findings. Am J Gastroenterol. (4 month old Indian female developed vomiting 1 hour after second ingestion of margosa oil [for cough], with drowsiness and acidosis [pH 6.8, bilirubin 0.2 mg/dL, AST 170 U/L, ALT 44 U/L, CPK 3180 U/L, prothrombin 16%], liver biopsy on day 5 showing microvesicular fat and mitochondrial abnormalities, died of cerebral edema on day 10).
Koga Y, Yoshida I, Kimura A, Yoshino M, Yamashita F, Sinniah D. (1987). Inhibition of mitochondrial functions by margosa oil: possible implications in the pathogenesis of Reye's syndrome. Pediatr Res. (Studies of isolated rat mitochondria demonstrated that margosa oil is a mitochondrial toxin, uncoupling respiratory chain enzymes and depleting ATP).
Sinniah R, Sinniah D, Chia LS, Baskaran G. (1989). Animal model of margosa oil ingestion with Reye-like syndrome. Pathogenesis of microvesicular fatty liver. J Pathol. (In mice, margosa oil causes rapid onset of mitochondrial injury, steatosis and glycogen depletion).
Subapriya R, Nagini S. (2005). Medicinal properties of neem leaves: a review. Curr Med Chem Anticancer Agents. (More than 140 compounds have been isolated from different parts of the neem tree and extracts of leaves, flowers, seeds, fruits, roots and bark have been used in traditional medicine for many medical conditions with little evidence of toxicity).
Senanayake MP, Rupasinghe S, Dissanayake PV. (2009). Margosa (Kohomba) oil induced toxic encephalopathy following home remedy for intestinal worms. Ceylon Med J. (14 month old boy developed vomiting, seizures and respiratory arrest hours after oral ingestion of a spoonful of margosa oil, presenting with hepatomegaly, no jaundice [ALT 120 U/L], and rapid and complete recovery).
Deng YX, Cao M, Shi DX, Yin ZQ, Jia RY, Xu J, Wang C, et al. (2013). Toxicological evaluation of neem (Azadirachta indica) oil: Acute and subacute toxicity. Environ Toxicol Pharmacol. (A four week course of neem oil in doses as high as 1.6 g/kg daily produced no acute or chronic toxicity in mice with no change in serum ALT levels and only mild congestion and fatty change in hepatocytes).
Giuggioli D, Lumetti F, Spinella A, Cocchiara E, Sighinolfi G, Citriniti G, Colaci M, et al. Use of Neem oil and Hypericum perforatum for treatment of calcinosis-related skin ulcers in systemic sclerosis. J Int Med Res 2019: Dec 25:300060519882176. (Application of a Neem oil containing topical solution to cutaneous ulcers in 21 patients with systemic sclerosis resulted in more rapid healing compared to a non-treated historical control group of 20 patients and was well tolerated without systemic adverse events).
Crighton E, Coghlan ML, Farrington R, Hoban CL, Power MWP, Nash C, Mullaney I, et al. (2019). Toxicological screening and DNA sequencing detects contamination and adulteration in regulated herbal medicines and supplements for diet, weight loss and cardiovascular health. J Pharm Biomed Anal. (Among 137 samples of herbal medications and supplements available in Australia that underwent toxicological and genetic analysis [DNA barcoding], 51% had additional plant DNA, one of which was Neem tree DNA, which was not declared on the product label).

## OTHER REFERENCE LINKS

1 Recent References on Margosa Oil: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Margosa+Oil+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Margosa Oil: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Margosa+Oil)